# Molnupiravir

## OVERVIEW

### Introduction

Molnupiravir is a ribonucleoside analogue and antiviral agent that is used in the therapy the severe acute respiratory syndrome (SARS) coronavirus 2 (CoV-2) infection, the cause of the novel coronavirus disease, 2019 (COVID-19). Molnupiravir therapy is given orally for 5 days early in the course of SARS-CoV-2 infection and has not been linked to serum aminotransferase elevations or to clinically apparent liver injury.

### Background

Molnupiravir (mole” nu peer’ a veer) is an orally absorbed, prodrug of the ribonucleoside analogue N-hydroxycytidine (NHC), which has activity in vitro against several coronaviruses including SARS-CoV-1 and -2. Once taken up in the replicating viral genome, NHC can base pair with either cytidine (the correct) or adenine (the incorrect ribonucleotide), thus causing lethal mutagenesis of the replicating virus. The efficacy of this somewhat unique mechanism of inhibition of viral replication depends upon the lack of proofreading by the viral RNA dependent RNA polymerase, and its safety depends upon effective proofreading by host DNA polymerases. Molnupiravir was found to be mutagenic in the Ames mutagenesis assay and in some but not all mammalian assays for host genetic mutations. In preregistration early phase trials, molnupiravir was found to be safe in doses of 400 to 1600 mg twice daily with adverse event rates no greater than with placebo and no apparent dose related toxicity. Trials of molnupiravir started within 5 days of onset of symptoms demonstrated a 30% to 50% reduction in subsequent clinical worsening of COVID-19, such that hospitalization was not required nor did the infection result in death. Based upon these results and the ongoing COVID-19 pandemic, molnupiravir was granted Emergency Use Authorization (EUA) in December 2021 as therapy of non-hospitalized adults with documented COVID-19 infection who are at high risk of complications. Molnupiravir is available under the EUA as 200 mg capsules, the recommended dose being four 200 mg capsules (800 mg) twice daily for 5 days. Longer term therapy is not recommended, nor is therapy recommended for hospitalized patients or patients who have had symptoms or signs for more than 5 days. Currently, molnupiravir is being actively evaluated for efficacy and safety in treating patients not at high risk for complications, for children, and for patients with known exposure to COVID-19 (post-exposure prophylaxis). Molnupiravir appears to be generally well tolerated; mild adverse events may include headache, dizziness, gastrointestinal upset, nausea and diarrhea. Molnupiravir is potentially teratogenic and is contraindicated in pregnancy. A potential side effect is impairment of bone and cartilage growth and it is not recommended for use in children. The total clinical experience with molnupiravir has been limited and its safety not fully defined.

### Hepatotoxicity

In preregistration clinical trials, serum aminotransferase elevations were uncommon and mild, and were no more frequent with molnupiravir than with placebo. Furthermore, among more than 900 patients treated with molnupiravir (800 mg twice daily) for 5 days in prelicensure studies, there were no reported episodes of clinically apparent liver injury. Confounding the issue is that serum aminotransferase elevations are common during symptomatic SARS-CoV-2 infection, present in up to 70% of patients and are more frequent in patients with severe disease and in those with the known risk factors for COVID-19 severity such as male sex, older age, higher body mass index and diabetes. Thus, molnupiravir has not been shown to cause liver injury, but the total clinical experience with its use is limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The lack of adverse events and hepatic injury from molnupiravir may be due to its lack of major hepatic metabolism and the relatively short duration of therapy. Molnupiravir is a prodrug that is absorbed orally and rapidly metabolized to NHC, which has little hepatic metabolism. Whether long term molnupiravir is also without serious adverse events remains to be seen. Studies in animal models have suggested that longer term therapy may result in thrombocytopenia and bone structural changes. Furthermore, the findings in mutagenesis studies suggest that molnupiravir may cause host DNA damage.

Drug Class: Antiviral Agents

Other Drugs in the Subclass: Paxlovid

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Molnupiravir – Generic

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Molnupiravir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Molnupiravir | 2492423-29-5 | C13-H19-N3-O7

## ANNOTATED BIBLIOGRAPHY

References updated: 31 January 2022

Abbreviations used: COVID-19, coronavirus disease, 2019; ICU, intensive care unit; IFN, interferon; IL, interleukin; MERS, Middle East respiratory syndrome; NHC, N-hydroxycytidine; SARS-CoV-2, severe acute respiratory syndrome-coronavirus 2.

Huang C, Wang Y, Li X, Ren L, Zhao J, Hu Y, Zhang L, et al. (2020). Clinical features of patients infected with 2019 novel coronavirus in Wuhan, China. Lancet. (Among 41 adults with COVID-19 pneumonia hospitalized in Wuhan China in December 2019-January 2020, 37% had serum AST elevations [62% of those in the ICU and 25% of those not] with concurrent elevations in proinflammatory cytokines [IL1B, IL6, IL2, IFN gamma], and 15% died).
Guan WJ, Ni ZY, Hu Y, Liang WH, Ou CQ, He JX, Liu L, et al. (2020). China Medical Treatment Expert Group for Covid-19. Clinical characteristics of coronavirus disease 2019 in China. N Engl J Med. (Among1099 patients hospitalized with COVID-19 at 552 hospitals in China through January 2020, the median age was 47 years, 42% were women, 2.4% were admitted to an ICU, 1.4% died and ALT elevations arose in 4.1%).
Qiu H, Wander P, Bernstein D, Satapathy SK. (2020). Acute on chronic liver failure from novel severe acute respiratory syndrome coronavirus 2 (SARS-CoV-2). Liver Int. (56 year old woman with decompensated alcoholic cirrhosis developed worsening jaundice and liver function when admitted with SARS-CoV-2 infection [bilirubin rising from 9.4 to ~17.8 mg/dL, ALT from 94 to ~275 U/L, AST from 184 to ~880 U/L, Alk P from 128 to ~195 U/L, INR from 1.92 to 2.6], improving back towards baseline as the infection resolved).
Wander P, Epstein M, Bernstein D. (2020). COVID-19 presenting as acute hepatitis. Am J Gastroenterol. (59 year old woman with HIV infection developed fatigue and jaundice [bilirubin 0.6 mg/dL, ALT 697 U/L, Alk P 145 U/L, INR 1.08] and then developed fever and cough with positive tests for SARS-CoV-1, liver tests falling over the next week as she recovered from COVID-19 ).
Bertolini A, van de Peppel IP, Bodewes FAJA, Moshage H, Fantin A, Farinati F, Fiorotto R, et al. (2020). Abnormal liver function tests in COVID-19 patients: relevance and potential pathogenesis. Hepatology. (Review of the prevalence and potential causes of abnormal liver tests in patients with SARS-CoV-2 infection, ALT elevations being reported in 4-39% of patients with higher rates in patients with more severe disease).
Hundt MA, Deng Y, Ciarleglio MM, Nathanson MH, Lim JK. (2020). Abnormal liver tests in COVID-19: A retrospective observational cohort study of 1827 patients in a major U.S. hospital network. Hepatology. (Among 1877 patients hospitalized with SARS-CoV-2 infection, serum ALT levels were elevated before hospitalization in 19%, at admission in 42% and a peak during hospitalization in 62%, with 21% being greater than 5 times ULN; elevations correlated with disease severity and its risk factors: male sex, older age, higher BMI and diabetes).
Painter WP, Holman W, Bush JA, Almazedi F, Malik H, Eraut NCJE, Morin MJ, et al. (2021). Human safety, tolerability, and pharmacokinetics of molnupiravir, a novel broad-spectrum oral antiviral agent with activity against SARS-CoV-2. Antimicrob Agents Chemother. (Among 64 healthy adults participating in a double-blind dose and safety trial, adverse events were less frequent with molnupiravir [50 to 1600 mg daily] than placebo and there were no clinically significant findings or dose related trends in laboratory values).
Zhou S, Hill CS, Sarkar S, Tse LV, Woodburn BMD, Schinazi RF, Sheahan TP, et al. (2021). β-d-N4-hydroxycytidine inhibits SARS-CoV-2 through lethal mutagenesis but Is also mutagenic to mammalian cells. J Infect Dis. (In cell culture, N-hydroxycytidine [NHC] had potent [EC_50_ 0.3 µM] activity against SARS-CoV-2 replication and created mutant viral genomes in a dose dependent manner, while ribavirin and favipiravir had minimal effects on replication and only at high concentrations; NHC also resulted in mutations in host genes in a mammalian cell culture system while ribavirin and favipiravir had minimal or no mutagenic effects).
Gordon CJ, Tchesnokov EP, Schinazi RF, Götte M. (2021). Molnupiravir promotes SARS-CoV-2 mutagenesis via the RNA template. J Biol Chem. (Studies with the SARS-CoV-2 RNA dependent RNA polymerase complex suggested that molnupiravir causes mutations in viral genomes by incorporation into the viral RNA template).
Kabinger F, Stiller C, Schmitzová J, Dienemann C, Kokic G, Hillen HS, Höbartner C, et al. (2021). Mechanism of molnupiravir-induced SARS-CoV-2 mutagenesis. Nat Struct Mol Biol. (In vitro assays demonstrated that molnupiravir is converted to N-hydroxycytidine [NHC] which can be used by the SARS-CoV-2 RNA dependent RNA polymerase to create negative strand viral RNA which is then used as a template for positive strand viral RNA, and since NHC can base pair with either cytidine or adenine, it can thus create mutations in subsequent negative strand synthesis).
Khoo SH, Fitzgerald R, Fletcher T, Ewings S, Jaki T, Lyon R, Downs N, et al. (2021). Optimal dose and safety of molnupiravir in patients with early SARS-CoV-2: a Phase I, open-label, dose-escalating, randomized controlled study. J Antimicrob Chemother. (Among 18 outpatients with documented SARS-CoV-2 infection started on molnupiravir [300, 400 or 800 mg] or placebo twice daily for 5 days within 5 days of onset, all patients tolerated therapy well with no serious adverse events; 1 of 12 patients on active drug had a mild, transient ALT elevation).
Fischer WA, Eron JJ, Holman W, Cohen MS, Fang L, Szewczyk LJ, Sheahan TP, et al. (2022). A Phase 2a clinical trial of molnupiravir in patients with COVID-19 shows accelerated SARS-CoV-2 RNA clearance and elimination of infectious virus. Sci Transl Med. (Among 202 unvaccinated patients with documented SARS-CoV-2 infection enrolled within 7 days of onset of symptoms who were treated with oral molnupiravir [200, 400 or 800 mg] or placebo twice daily for 5 days, the median time to clearance of nasal swab SARS-CoV-2 RNA was shorter with 800 mg daily [15 days] than placebo [14 days] and adverse event rates were lower with active drug, ALT elevations occurring in 2.8% vs 3.2% and there were no serious adverse events).
Jayk Bernal A, Gomes da Silva MM, Musungaie DB, Kovalchuk E, Gonzalez A, Delos Reyes V, Martín-Quirós A, et al., MOVe-OUT Study Group. (2021). Molnupiravir for oral treatment of Covid-19 in nonhospitalized patients. N Engl J Med. (Among 1433 outpatients at high risk of complications of COVID-19 started on oral molnupiravir or placebo within 5 days of onset of symptoms or signs, rates of hospitalization [6.8% vs 9.7%] and deaths within 29 days [0.1% vs 1.3%] were less with molnupiravir than placebo, while adverse event rates were similar [30%vs 33%]; no mention of ALT elevations or hepatotoxicity).
Whitley R. (2021). Molnupiravir – A step toward orally bioavailable therapies for Covid-19. N Engl J Med. (Editorial in response to Jayk Bernal [2021] mentions that response rates with molnupiravir were greater in the interim analysis [50%] than the final analysis [30%] of the MOVe-OUT trial, and that starting antiviral therapy early appears to be crucial in achieving a response in COVID-19).
Couzin-Frankel J. (2021). Antiviral pills could change pandemic's course. Science. (News report of the promise of antivirals including Paxlovid and molnupiravir as a means of treatment for early SARS-CoV-2 infection; no discussion of adverse events).
Molnupiravir for treatment of COVID-19. (2022). Med Lett Drug Ther. (Concise review of the mechanism of action, clinical efficacy, safety and indications of molnupiravir shortly after its Emergency Use Authorization in the US mentions mild adverse events arising during the 5 day treatment including diarrhea, nausea and dizziness and potential risks of embryofetal toxicity and impaired bone and cartilage growth; no mention of ALT levels or liver injury).
Law MF, Ho R, Law KWT, Cheung CKM. (2021). Gastrointestinal and hepatic side effects of potential treatment for COVID-19 and vaccination in patients with chronic liver diseases. World J Hepatol. (Summary of the therapies for COVID-19 therapy and their potential for causing liver injury mentions that ALT elevations have occurred in some patients treated with molnupiravir).

## OTHER REFERENCE LINKS

1 Recent References on Molnupiravir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Molnupiravir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Molnupiravir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Molnupiravir)